# Dicloxacillin

## OVERVIEW

### Introduction

Dicloxacillin is an oral, second generation penicillin antibiotic that is used to treat bacterial infections caused by penicillinase-resistant staphylococci. Dicloxacillin has been linked to rare instances of clinically apparent, idiosyncratic liver injury.

### Background

Dicloxacillin (dye klox' a sil' in) is a second generation penicillin that is resistant to inactivation by penicillinases and is used to treat infections caused by penicillinase-producing bacteria. Like other penicillins, dicloxacillin is a beta lactam antibiotic that is believed to act by binding to the bacterial enzyme that is responsible for synthesizing peptidoglycans which are necessary for the integrity of the bacterial cell wall. Dicloxacillin was approved for use in the United States in 1968 and is still widely used to treat mild-to-moderate staphylococcal infections. To reduce development of drug resistant bacteria, dicloxacillin is recommended to treat or prevent only those infections that are proven or suspected to be caused by penicillinase-producing susceptible bacteria. Dicloxacillin is available in multiple generic forms as 250 and 500 mg capsules and as a suspension for pediatric use. The typical dose is 125 to 500 mg every 6 hours. Common side effects of dicloxacillin include nausea, diarrhea, stomatitis, skin rash, and allergic reactions. Rare but potentially severe adverse events include anaphylaxis, Clostridium difficile diarrhea, and neutropenia.

### Hepatotoxicity

Dicloxacillin therapy has not been associated with serum enzyme elevations during treatment, but has been linked to rare instances of clinically apparent, cholestatic hepatitis. The typical time to onset is 1 to 6 weeks and the pattern of serum enzyme elevations is usually cholestatic, although cases with a mixed pattern have also been described (Case 1). The injury usually presents with jaundice and pruritus. Fever, rash and eosinophilia can occur, but are not prominent, and autoantibodies are rarely detected. A similar pattern of injury occurs more frequently with flucloxacillin (also called floxacillin) and cloxacillin, two oral isoxazolyl penicillins similar in structure and activity to dicloxacillin, but not available for use in the United States. Similar cholestatic hepatitis arising 1 to 6 weeks after starting therapy occurs with other penicillins.

Likelihood score: B (highly likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the idiosyncratic, cholestatic hepatitis following dicloxacillin therapy is not known. Allergic manifestations (rash, fever and eosinophilia) are not common and the liver injury is usually not accompanied by signs or symptoms of penicillin hypersensitivity. However, the rapid recurrence of injury with reexposure suggests a hypersensitivity mechanism, perhaps in response to the beta lactam ring. Injury occurs more frequently in older patients. Too few cases of dicloxacillin hepatotoxicity have been reported to comment on possible HLA associations, such as the link to HLA-B*57:01 which has been made to flucloxacillin.

### Outcome and Management

In the few cases that have been described, cholestasis has been prolonged, but all patients recovered clinically within 6 to 12 weeks, although some had evidence of residual injury. Reexposure appears to be associated with recurrence of injury, often with a shortened latency period. The idiosyncratic liver injury from dicloxacillin has not been linked to acute liver failure or the vanishing bile duct syndrome (although these have been described with similar cases due to flucloxacillin). Prednisone has been used to treat the cholestatic liver injury, but its effects are unclear while its side effects can be serious. Patients should be told to avoid reexposure to the penicillinase-resistant penicillins, including nafcillin and oxacillin.

Drug Class: Penicillin (Penicillinase-Resistant)

## CASE REPORT

### Case 1. Cholestatic hepatitis caused by dicloxacillin.(1)

A 56 year old man received a 5-day course of oral dicloxacillin (250 mg four times a day) and 2 weeks later developed gastrointestinal discomfort, followed by fever and then jaundice and itching. He had a history of hepatitis 22 years ago, but no other significant medical history and had no current risk factors for viral hepatitis. He took no other medications, had no allergies, and drank little alcohol. On admission, his serum bilirubin was 3.8, that subsequently rose to a peak of 11.8 mg/dL 4 weeks later (Table). Eosinophil counts were normal. Tests for acute hepatitis A and B were negative, and abdominal ultrasound was normal. After several weeks, he began to improve, and laboratory abnormalities returned to normal 14 weeks after he had started the course of antibiotics.

#### Key Points

Medication: | Dicloxacillin
Pattern: | Mixed (R=2.6)
Severity: | 3+ (jaundice and hospitalization)
Latency: | Two to three weeks
Recovery: | Complete in 3 months
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | AST* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Comments
0 | | Dicloxacillin given for 5 days
3 weeks | 2 weeks | 225 | 218 | 3.8 | Eosinophils=487
4 weeks | 3 weeks | 325 | 230 | 8.0
5 weeks | 4 weeks | 50 | 150 | 10.3
7 weeks | 6 weeks | 45 | 165 | 11.8
8 weeks | 7weeks | 60 | - | 9.8
9 weeks | 8 weeks | 110 | - | 5.0
10 weeks | 9 weeks | 80 | 170 | 3.2
12 weeks | 11 weeks | 70 | 135 | 1.8
13 weeks | 12 weeks | 65 | 120 | 1.1
14 weeks | 13 weeks | 38 | 60 | 0.5
Normal Values | | <40 | <100 | <1.2

* Estimates made from Figure 1.

#### Comment

The appearance of jaundice and itching 3 weeks after starting a 5-day course of dicloxacillin with a mixed pattern of serum enzyme elevations (later becoming more cholestatic) is fully compatible with dicloxacillin-induced liver injury. Recovery was somewhat slow, but was complete by 3 months. Idiosyncratic drug induced liver injury from dicloxacillin is rare and only isolated case reports have been published. More common and with a similar pattern of injury are cases of flucloxacillin (which was approved and used in Australia and Europe, but not in the United States). Flucloxacillin hepatotoxicity is characterized by a latency of 2 to 6 weeks (often arising 1 to 3 weeks after stopping therapy), with a cholestatic or mixed enzyme pattern and recovery in 1 to 3 months. Fatalities and vanishing bile duct syndrome have been reported with flucloxacillin, but not with dicloxacillin despite the similarity of the injury caused, probably because dicloxacillin is just much less likely to lead to hepatic injury, and there are fewer cases.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dicloxacillin – Generic

DRUG CLASS

Penicillin (Penicillinase-Resistant)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=dicloxacillin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Dicloxacillin | 3116-76-5 | C19-H17-Cl2-N3-O5-S | SID: 134981835

## CITED REFERENCE

1 Kleinman MS, Presberg JE. Cholestatic hepatitis after dicloxacillin-sodium therapy. J Clin Gastroenterol 1986; 8: 77-8.3701014

## ANNOTATED BIBLIOGRAPHY

References updated: 09 August 2026

Zimmerman HJ. Synthetic penicillins. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p. 596-8. (Expert review of penicillins and liver injury published in 1999).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics mentions that liver injury from the penicillins is very rare, and is usually cholestatic for the oxypenicillins such as dicloxacillin and cloxacillin).
MacDougall C. Penicillins, cephalosporins, and other β-lactam antibiotics. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1023-38. (Textbook of pharmacology and therapeutics).
Kleinman MS, Presberg JE. Cholestatic hepatitis after dicloxacillin-sodium therapy. J Clin Gastroenterol 1986; 8: 77-8. (56 year old man developed jaundice and pruritus 2-3 weeks after a 5 day course of dicloxacillin [bilirubin rising to 13 mg/dL, AST 225 U/L, Alk P 318 U/L], without rash, eosinophilia or fever, requiring 10 weeks to resolve). 3701014
Siegmund JB, Tarshis AM. Prolonged jaundice after dicloxacillin therapy. Am J Gastroenterol 1993; 88: 1299-300. (36 year old woman developed fatigue and jaundice 3 weeks after starting dicloxacillin [bilirubin 18.2 mg/dL, ALT 100 U/L, Alk P 312 U/L], with slow recovery even with prednisone; 3 years later, enzymes were still mildly elevated [ALT 44 U/L, Alk P 188 U/L]). 8338117
Saab S, Venkataramani A, Yao F. Possible granulomatous hepatitis after dicloxacillin therapy. J Clin Gastroenterol 1996; 22: 163-4. (74 year old developed rash 5 days after starting oral dicloxacillin [bilirubin 0.5 mg/dL, ALT 172 U/L, Alk P 183 U/L], biopsy showing a single granuloma and mild nonspecific changes, ultimately resolving within 4 months of stopping). 8742666
Ibáñez L, Pérez E, Vidal X, Laporte JR; Grup d'Estudi Multicènteric d'Hepatotoxicitat Aguda de Barcelona (GEMHAB). Prospective surveillance of acute serious liver disease unrelated to infectious, obstructive, or metabolic diseases: epidemiological and clinical features, and exposure to drugs. J Hepatol 2002; 37: 592-600. (Survey of 107 cases of acute serious liver disease, not due to viruses, found no instances of drug induced liver injury due to penicillinase-resistant penicillins). 12399224
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Analysis of all fatal adverse drug event reports of liver injury in Sweden between 1966 and 2002, found 103 cases; most common causes were halothane [n=16], acetaminophen [14], flucloxacillin [9], and TMP-SMZ [6]). 16165719
Hussaini SH, O'Brien CS, Despott EJ, Dalton HR. Antibiotic therapy: a major cause of drug-induced jaundice in southwest England. Eur J Gastroenterol Hepatol 2007; 19: 15-20. (Review of causes of non-obstructive jaundice in 347 patients presenting between 1998 and 2004 at a single UK center, 28 were thought to be drug induced liver injury [8.1%] and antibiotics were the most common cause, 32% amoxicillin/clavulanate, 25% flucloxacillin, 18% other). 17206072
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, antimicrobials accounted for 45% of cases with 23 single agent cases due to amoxicillin/clavulanate, 13 nitrofurantoin, 10 fluoroquinolones, 9 macrolides, 9 sulfonamides, 5 cephalosporins, 3 oxacillin, 2 doxycycline, 2 amoxicillin, and one each for gentamicin, imipenem, and clindamycin, but none from dicloxacillin or nafcillin). 18955056
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; leading causes were antituberculosis agents [58%], anticonvulsants [11%] and NSAIDs [2%]; specific antibiotic agents included sulfamethoxazole/trimethoprim [2%] and amoxicillin-clavulanate [1%]). 20648003
Ferrajolo C, Capuano A, Verhamme KMC, Schuemie M, Rossi F, Stricker BH, Sturkenboom CJM. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Among 624,673 adverse drug reports in children in a worldwide pharmacovigilance database, 6595 [1%] were for hepatic injury and antibacterials accounted for 11%, those with the highest adjusted odds ratios being aztreonam, erythromycin, ceftriaxone and minocycline; no mention of penicillins). 21039766
Daly AK, Donaldson PT, Bhatnagar P, Shen Y, Pe'er I, Floratos A, Daly MJ, et al. HLA-B*5701 genotype is a major determinant of drug-induced liver injury due to flucloxacillin. Nature Genetics 2009; 41: 816-9. (Genome-wide association study [GWAS] in 51 cases of flucloxacillin liver injury and 285 controls found an association with a single nucleotide polymorphism linked to HLA-B*5701 [84% in cases vs 5% in controls], the same genotype associated with abacavir hypersensitivity; ~0.2% of persons with this HLA type receiving flucloxacillin develop cholestatic hepatitis, making it likely that other genes or factors are important as well). 19483685
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 66 due to antimicrobial agents, but none were attributed to a penicillinase-resistant penicillin). 20949552
Daly AK. Genome-wide association studies in pharmacogenomics. Nat Rev Genet 2010; 11: 241-6. (Review of recent advances in GWAS studies of pharmacokinetics and adverse drug reactions and association of flucloxacillin injury with HLA-B*5701). 20300088
Monshi MM, Faulkner L, Gibson A, Jenkins RE, Farrell J, Earnshaw CJ, Alfirevic A, et al. Human leukocyte antigen (HLA)-B*57:01-restricted activation of drug-specific T cells provides the immunological basis for flucloxacillin-induced liver injury. Hepatology 2013; 57: 727-39. (T cells from persons with HLA-B*57:01 were activated when exposed to dendritic cells presenting flucloxacillin bound to albumin, and were similarly activated by oxacillin, cloxacillin and dicloxacillin). 22987284
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 due to amoxicillin/clavulanate, 1 to dicloxacillin [2nd generation] and 1 to phenoxymethylpenicillin [1st generation], the latter two cases being anicteric). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, Chirino RA, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury from Latin American countries published between 1996 and 2012 identified 176 cases, of which 37 [19%] were attributed to antimicrobials, but none to penicillinase resistant penicillins such as oxacillin or dicloxacillin). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug-Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 cases [36%] were attributed to antibiotics 3 of which were due to oxacillin, all being self-limited episodes of aminotransferase elevations without jaundice; no instances of dicloxacillin or nafcillin associated liver injury). 25754159
Nicoletti P, Aithal GP, Bjornsson ES, Andrade RJ, Sawle A, Arrese M, Barnhart HX, et al.; International Drug-Induced Liver Injury Consortium, Drug-Induced Liver Injury Network Investigators, and International Serious Adverse Events Consortium. Association of liver injury from specific drugs, or groups of drugs, with polymorphisms in HLA and other genes in a genome-wide association study. Gastroenterology 2017;152:1078-89. (A genome-wide association study done on 862 patients with drug induced liver injury demonstrated a strong link with HLA-A*33:01 in patients with cholestatic liver injury, particularly in cases attributed to terbinafine, fenofibrate and ticlopidine). 28043905
Cirulli ET, Nicoletti P, Abramson K, Andrade RJ, Bjornsson ES, Chalasani N, Fontana RJ, et al.; Drug-Induced Liver Injury Network (DILIN) investigators; International DILI consortium (iDILIC). A missense variant in PTPN22 is a risk factor for drug-induced liver injury. Gastroenterology 2019; 156: 1707-1716.e2. (Genome-wide association studies on 2048 patients with drug-induced liver injury and 12,439 controls identified a variant in PTPN22 which was highly associated with liver injury, allele frequency being 0.12 among cases and 0.08 among controls with highest association in Northern Europeans and in cases of amoxicillin clavulanate, PTPN22 being a cellular kinase involved in modulation of immune reactions). 30664875
Nicoletti P, Aithal GP, Chamberlain TC, Coulthard S, Alshabeeb M, Grove JI, Andrade RJ, et al; International Drug-Induced Liver Injury Consortium (iDILIC). Drug-induced liver injury due to flucloxacillin: relevance of multiple human leukocyte antigen alleles. Clin Pharmacol Ther. 2019;106:245-253. (Among 197 patients with flucloxacillin-induced liver injury, genome wide association studies demonstrated a strong association with HLA-B*57:01 compared to controls [AF .42 vs .04], but the allele was not found increased among 6 patients with oxacillin-, dicloxacillin-. or cloxacillin-induced liver injury or in 15 with amoxicillin-induced liver injury). 30661239
Hashim A, Barnabas A, Miquel R, Agarwal K. Successful liver transplantation for drug-induced vanishing bile duct syndrome. BMJ Case Rep. 2020;13:e233052. (63-year-old woman developed jaundice 4 days after finishing a 10-day course of flucloxacillin for a skin infection [bilirubin 29.3 mg/dL, ALT 60 U/L, Alk P 287 U/L] with progressive cholestasis leading to liver transplantation 6 months after initial onset). 31948982
Khatib S, Sabobeh T, Bock MD, Masoud A, Alallaf J. Nafcillin-induced hepatic injury: a case report and literature review. Cureus. 2021;13:e12817. (66-year-old man with toe infection developed jaundice 9 days after finishing an 18-day course of iv nafcillin [bilirubin 6.2 mg/dL, ALT 415 U/L, Alk P 506 U/L] which worsened for a few days but then gradually resolved completely without corticosteroids or other specific therapy). 33628683
Angheleanu R, Swart JN. Flucloxacillin-induced liver injury in elderly patient. BMJ Case Rep. 2021;14:e241071. (A 91-year-old woman developed dark urine, jaundice, and confusion 3 to 4 weeks after a 7- and then a 5-day course of flucloxacillin for cellulitis [bilirubin 14 mg/dL, ALT 116 U/L, Alk P 1083 U/L, INR 1.5] but ultimately improved with supportive therapy only and her condition “settled slowly” for the next 4 weeks). 33958360
Faragalla K, Lau H, Wang HL, Liu J. Cloxacillin-induced acute vanishing bile duct syndrome: a case study and literature review. Br J Clin Pharmacol. 2022;88:4633-4638. (66-year-old woman with cerebral vascular disease developed weakness and progressive jaundice a week after finishing a 6-week course of cloxacillin and sought medical care 2 weeks later [bilirubin of 44 mg/dL, ALT 877 U/L, Alk P 4279 U/L, eosinophils 1,200/μL], with persistence of jaundice and liver biopsy showing ductopenia was referred for liver transplant but died of complications before surgery). 35730139
Coombs S, Pittet LF, Tang K, Gwee A. Incidence and predisposing factors for flucloxacillin-related hepatotoxicity in children. J Antimicrob Chemother. 2023;78:2667-2671. (Among 393 children treated with iv flucloxacillin who had liver tests taken before and after therapy, 66 developed “hepatotoxicity” which was mostly isolated elevations in GGT, ALT, AST, or bilirubin with no serious outcomes or persistent injury). 37699070
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1,739 hospitalizations for acute liver injury suspected to be due to outpatient prescribed medications none of which were attributed to a penicillinase-resistant penicillin). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 468 cases of drug-induced liver injury enrolled in a prospective Latin American database only 1 was attributed to oxacillin and none to other penicillinase-resistant penicillins: personal communication). 38992407
Huang YT, Huang YM, Lee NC, Lee PI, Ho YF. Medication hazards and outcome patterns of pediatric drug-associated liver injury in Taiwan: an analysis of 1998-2017 spontaneous adverse drug reaction reports. Drugs Real World Outcomes. 2025;12:105-114. (Among 16,673 spontaneous reports of adverse drug reactions in children made to a Taiwanese national registry between 1998 and 2017, 484 were liver related and attributed to 193 different drugs the most frequent implicated being oxacillin [25 reports] followed by methotrexate [20], phenobarbital [13], phenytoin [10] and valproate [10]; no mention of dicloxacillin). 39775441
Nibell O, Björk J, Nilsson A, Jacobsson G, Inghammar M. The risk of drug-induced liver injury associated with flucloxacillin: a nationwide, entropy-balanced cohort study. Clin Microbiol Infect. 2025;31:600-606. (Analysis of Swedish national registries of drug prescriptions and cases of drug induced liver disease occurring within 45 days of the prescription between 2006 and 2018 yielded rough estimates for incidence of liver injury as 1 in 525 cases per person exposed to flucloxacillin [219 cases in 1,129,091 individuals] vs 1 in 5,250 exposed to clindamycin [9 cases in 471,666]). 39716553

## OTHER REFERENCE LINKS

1. Recent References on Dicloxacillin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Dicloxacillin/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))

2. Trials on Dicloxacillin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=dicloxacillin)